# Diphenhydramine

## OVERVIEW

### Introduction

Diphenhydramine is a first generation antihistamine that is used for symptoms of allergic rhinitis and the common cold. It is also commonly used as a mild sleeping aid. Diphenhydramine has not been linked to instances of clinically apparent acute liver injury.

### Background

Diphenhydramine (dye" fen hye' dra meen) is a first generation antihistamine that is used widely in the therapy of the symptoms of allergic rhinitis and the common cold, including sneezing, cough, runny note, watery eyes and itching. Because of its sedating side effects, it is also used as a mild sleeping aid. In intravenous forms, diphenhydramine is used in the treatment of severe allergic reactions and anaphylaxis. Diphenhydramine belongs to the ethanolamine class of antihistamines (with clemastine and dimenhydrinate) and in 1946 became the first antihistamine approved for use in the United States. It is still widely used today and is available in multiple generic forms as tablets, capsules, liquid oral and intravenous solutions, creams and syrups, many of which are available without prescription. A common brand name is Benadryl. Diphenhydramine is often combined with other analgesics or sympathomimetic agents for combined relief of symptoms of allergic rhinitis and the common cold. The recommended adult oral dose ranges from 25 to 50 mg three or four times daily. Common side effects include sedation, impairment of motor function, confusion, dizziness, blurred vision, dry mouth and throat, palpitations, tachycardia, abdominal distress, constipation and headache. Antihistamines can worsen urinary retention and glaucoma.

### Hepatotoxicity

Despite widespread use over many decades, diphenhydramine has not been linked to liver test abnormalities or to clinically apparent liver injury. The reason for its safety may relate its short half-life and limited duration of use.

Likelihood score: E (unlikely to be a cause of clinically apparent liver injury).

References on the safety and potential hepatotoxicity of antihistamines are given together after the Overview section on Antihistamines.

Drug Class: Antihistamines

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Diphenhydramine – Generic, Benadryl®

DRUG CLASS

Antihistamines

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Diphenhydramine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Diphenhydramine | 58-73-1 | C17-H21-N-O | Diphenhydramine Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Diphenhydramine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Diphenhydramine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Diphenhydramine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Diphenhydramine)